# Bisacodyl

## OVERVIEW

### Introduction

Bisacodyl is commonly used, over-the-counter laxative used to treat constipation or bowel irregularity. Bisacodyl has not been associated with serum enzyme elevations during therapy or with clinically apparent liver injury with jaundice.

### Background

Bisacodyl (bis ak’ oh dil) is a mild laxative that is available over-the-counter and is commonly used to treat mild constipation and bowel irregularity. Bisacodyl is believed to act by direct stimulation of intestinal peristalsis. Bisacodyl is a diphenylmethane derivative and is structurally similar to phenolphthalein. It is administered in an enteric coated form and is minimally absorbed, acting locally on the large intestine. Bisacodyl has been in general use since the 1950s and is available in multiple forms including tablets of 5 mg, suppositories of 10 mg and as a liquid solution for oral use generically and under multiple trade names such as Dulcolax, Fleet’s enema, Correctal and Carter’s Little Pills. Bisacodyl is often used for bowel cleansing before operations or colonoscopy. Common side effects include abdominal pain, bloating and diarrhea.

### Hepatotoxicity

Bisacodyl has not been associated with serum enzyme elevations during therapy or with instances of clinically apparent liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Bisacodyl is minimally absorbed and its metabolism has not been well characterized, but it is given in low doses only and generally for short periods of time.

Drug Class: Gastrointestinal Agents, Cathartics and Laxatives

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bisacodyl – Generic, Dulcolax®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Bisacodyl)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Bisacodyl | 603-50-9 | C22-H19-N-O4 | Bisacodyl Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 29 September 2017

Zimmerman HJ. Antiemetic and prokinetic compounds. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 721. (Expert review of hepatotoxicity published in 1999 does not discuss bisacodyl).
Sharkey KA, Wallace JL. Treatment of disorders of bowel motility and water flux: anti-emetics; agents used in biliary and pancreatic disease. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1323-50. (Textbook of pharmacology and therapeutics).
Ramkumar D, Rao SS. Efficacy and safety of traditional medical therapies or chronic constipation: systematic review. Am J Gastroenterol 2005; 100: 936-71. (Systematic review of the literature for controlled trials of traditional therapies for constipation reported "a paucity of trials for many commonly used agents", including bisacodyl and docusate). 15784043
Kienzle-Horn S, Vix JM, Schuijt C, Peil H, Jordan CC, Kamm MA. Efficacy and safety of bisacodyl in the acute treatment of constipation: a double-blind, randomized, placebo-controlled study. Aliment Pharmacol Ther 2006; 23: 1479-88. (Among 55 patients with idiopathic constipation treated with bisacodyl [10 mg once daily] or placebo for 3 days, there were no differences in side effects or "clinically meaningful differences" in serum chemistry results between the bisacodyl and placebo groups). 16669963
Kienzle-Horn S, Vix JM, Schuijt C, Peil H, Jordan CC, Kamm MA. Comparison of bisacodyl and sodium picosulphate in the treatment of chronic constipation. Curr Med Res Opin 2007; 23: 691-9. (Among 144 patients with constipation treated with bisacodyl or sodium picosulphate for 4 weeks, there was improvement in symptoms of constipation in both groups and side effects included abdominal pain and diarrhea; there were no significant changes in laboratory values including electrolytes and serum bilirubin). 17407625
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, no cases were attributed to laxatives). 18955056
Mueller-Lissner SA, Wald A. Constipation in adults. Clin Evid (Online) 2010 Jul 5; 2010. pii: 0413. (Review of evidence of efficacy of conventional therapies of constipation). 21418672
Kamm MA, Mueller-Lissner S, Wald A, Richter E, Swallow R, Gessner U. Oral bisacodyl is effective and well-tolerated in patients with chronic constipation. Clin Gastroenterol Hepatol 2011; 9: 577-83. (Among 368 patients with constipation treated with bisacodyl [10 mg] or placebo once daily for 4 weeks, numbers of bowel movements increased more in the bisacodyl [from 1.1 to 5.2 weekly] than the placebo recipients [1.1 to 1.9]; side effects included diarrhea [52% vs 1.7%] and abdominal pain [25% vs 2.5%], ALT levels were not determined and there were no serious adverse events attributed to bisacodyl). 21440672
Gerard DP, Holden JL, Foster DB, Raiser MW. Randomized trial of gatorade/polyethylene glycol with or without bisacodyl and NuLYTELY for colonoscopy preparation. Clin Transl Gastroenterol 2012; 3: e16. (Among 600 patients scheduled for colonoscopy and undergoing bowel preparation with polyethylene glycol with or without bisacodyl and "NuLytely", patients receiving bisacodyl had more side effects [mostly abdominal bloating] without a significantly better colon preparation). 23238266
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to laxatives). 23419359
Müller-Lissner S. Pharmacokinetic and pharmacodynamic considerations for the current chronic constipation treatments. Expert Opin Drug Metab Toxicol 2013; 9: 391-401. (Review of the pharmacology, efficacy and safety of medications for constipation mentions that bisacodyl is minimally absorbed and is generally accepted as being safe). 23425050
Kim HJ, Lee JH, Park HJ, Cho SH, Cho S, Kim WS. Monitoring of 29 weight loss compounds in foods and dietary supplements by LC-MS/MS. Food Addit Contam Part A Chem Anal Control Expo Risk Assess 2014; 31: 777-83. (Among 188 samples of 29 weight loss compounds sold as dietary supplements in Korea, 62 [33%] were found to be adulterated with conventional medications, including 7.1% with detectable levels of bisacodyl). 24499058
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to bisacodyl or other laxatives). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Bisacodyl: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Bisacodyl+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Bisacodyl: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bisacodyl)